# Rilzabrutinib

## OVERVIEW

### Introduction

Rilzabrutinib is an orally available inhibitor of Bruton tyrosine kinase that is used to treat patients with chronic immune thrombocytopenia. Rilzabrutinib has been associated with a low rate of serum aminotransferase elevations during therapy but has not, as yet, been linked to instances of clinically apparent liver injury.

### Background

Rilzabrutinib (ril” za broo’ ti nib) is a small molecule, reversible inhibitor of Bruton tyrosine kinase, an enzyme important in B cell activation and antibody production and in Fc gamma receptor-mediated phagocytosis in the spleen and liver. By inhibiting the kinase, rilzabrutinib is believed to decrease antiplatelet antibody production and platelet destruction, actions that account for its efficacy in immune thrombocytopenia. Rilzabrutinib was approved for use in the United States in 2025 and is indicated for adults with persistent or chronic immune thrombocytopenia who have had an insufficient response to a previous treatment. Rilzabrutinib is available in tablets of 400 mg under the brand name Wayrilz. The usual adult dose is 400 mg twice daily. Rilzabrutinib is also under evaluation in other autoimmune conditions. Common side effects are usually mild and can include diarrhea, nausea, headache, abdominal pain, and upper respiratory infections. Rare but potentially serious adverse events include serious infections, hepatotoxicity, and, based upon studies in laboratory animals, embryo-fetal toxicity.

### Hepatotoxicity

In a pre-registration, controlled trial, serum aminotransferase elevations occurred in a small proportion of patients treated with rilzabrutinib but were largely transient and mild to moderate in severity. Elevations of ALT above 3 times the upper limit of normal (ULN) occurred in 3% of patients on rilzabrutinib vs 2% on placebo and were above 5 times the ULN in 0.8% vs 1.5%. One rilzabrutinib recipient with pre-existing cirrhosis and recurrent esophageal variceal bleeding had an ALT elevation above 10 times the ULN, but the episode was considered unrelated to rilzabrutinib therapy. No recipient developed clinically apparent liver injury with jaundice that was attributed to rilzabrutinib, and expert review of the potential cases identified an alternative explanation in each instance. In controlled trials of rilzabrutinib in other autoimmune conditions (pemphigus, chronic urticaria, atopic dermatitis), therapy was associated with low rates of ALT elevations, which were often higher than rates in placebo- treated subjects, but none of the elevations were persistent or associated with symptoms or jaundice. Since its recent approval, there have been no published reports of clinically apparent liver injury attributed to rilzabrutinib, but clinical experience with the drug has been limited.

Hepatotoxicity, including severe and potentially fatal instances of clinically apparent liver injury with jaundice, has been reported with other, mostly irreversible Bruton kinase inhibitors, and this class effect is the basis for the warning in the product label. Whether rilzabrutinib carries a similar risk is not yet established.

Likelihood score: E* (suspected but unproven cause of clinically apparent liver injury).

### Mechanism of Injury

The mild aminotransferase elevations that occur during rilzabrutinib therapy may be due to a toxic intermediate of its metabolism, with reversal of these elevations attributable to adaptation. Rilzabrutinib is metabolized in the liver largely by CYP 3A4, and its exposure is markedly increased by CYP 3A inhibitors and in the presence of moderate hepatic impairment. The hepatotoxicity of the Bruton tyrosine kinase inhibitor class is not well understood but may involve direct toxicity, off-target kinase inhibition, or immune-mediated injury, including reactivation of hepatitis B.

### Outcome and Management

The product label for rilzabrutinib recommends measuring routine liver tests before starting therapy and as clinically indicated during treatment. In patients who develop abnormal liver tests, more frequent monitoring is advised, and rilzabrutinib should be withheld if drug-induced liver injury is suspected and discontinued if it is confirmed. Rilzabrutinib should be avoided in patients with moderate or severe hepatic impairment because of the potential for markedly increased drug exposure.

Drug Class: Hematologic Agents, Protein Kinase Inhibitors

Other Drugs in the Subclass: Acalabrutinib, Ibrutinib, Pirtobrutinib, Zanubrutinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Rilzabrutinib – Wayrilz®

DRUG CLASS

Hematologic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Rilzabrutinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Rilzabrutinib | 1575591-66-0 | C36H40FN9O3 | SID: 505879567

## ANNOTATED BIBLIOGRAPHY

References updated: 22 September 2026

Abbreviations used: ULN, upper limit of normal.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999, before the availability of rilzabrutinib).
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2025/219685Orig1s000IntegratedR.pdf (FDA website with the product label and integrated review of the efficacy and safety of rilzabrutinib based upon data provided by the sponsor in support of its approval as therapy of immune thrombocytopenia, mentions that among 133 patients treated with rilzabrutinib vs 69 on placebo, ALT elevations above 3 times ULN occurred in 3.1% vs 1.5% and above 5 times ULN in 0.8% vs 1.5%, that one rilzabrutinib recipient had an ALT above 10 times ULN attributed to underlying cirrhosis and variceal bleeding, and that expert review concluded none of the potential cases represented drug-induced liver injury).
Kuter DJ, Efraim M, Mayer J, Alexander S, Cooper N, Tarantino M, Provan D, et al. Rilzabrutinib, an oral BTK inhibitor, in immune thrombocytopenia. N Engl J Med. 2022;386:1421-1431. (Among 60 patients with relapsed immune thrombocytopenia treated with rilzabrutinib in doses up to 400 mg twice daily for 24 weeks, 40% had a platelet response and adverse events were transient and mild or moderate in severity and transient; no mention of ALT elevations or hepatotoxicity). 35417637
Kuter DJ, Mayer J, Efraim M, Bogdanov LH, Baker R, Kaplan Z, Garg M, et al. Long-term treatment with rilzabrutinib in patients with immune thrombocytopenia. Blood Adv. 2024;8:1715-1724. (Among 16 patients continuing rilzabrutinib 400 mg twice daily for a median of 478 days in an open label extension trial, platelet responses were durable and adverse events were mild to moderate in severity, with a single transient and asymptomatic ALT elevation of 3 times ULN which resolved without dose interruption). 38386978
Murrell DF, Caux F, Patsatsi A, Hagino O, Rudnicka L, Vassileva S, Uzun S, et al. Efficacy and safety of rilzabrutinib in pemphigus: PEGASUS Phase 3 Randomized Study. J Invest Dermatol. 2024;144:1762-1771.e6. (Among 111 adults with pemphigus treated with rilzabrutinib [400 mg twice daily] vs placebo for 24 weeks, complete clinical responses arose in 26% vs 18%, while treatment related adverse events occurred in 25% vs 21% and severe adverse events in 9% vs 15%, adverse events more frequent with rilzabrutinib included bruising [25% vs 11%], myopathy [23% vs 15%], insomnia [18% vs 9%], depression [17% vs 9%], headache [14% vs 8%], and ALT elevations [6% vs none]; degree of ALT elevation not provided). 38493933
Cooper N, Jansen AJG, Bird R, Mayer J, Sholzberg M, Tarantino MD, Garg M, et al. Efficacy and safety results with rilzabrutinib, an oral Bruton tyrosine kinase inhibitor, in patients with immune thrombocytopenia: phase 2 Part B study. Am J Hematol. 2025;100:439-449. (Among 26 patients with refractory immune thrombocytopenia treated with rilzabrutinib [400 mg twice daily] for 24 weeks, 9 patients [35%] had a durable platelet response while adverse events included diarrhea, headache, and nausea, but there were no treatment-related serious adverse events; no mention of ALT elevations or hepatotoxicity). 39844469
Kuter DJ, Ghanima W, Cooper N, Liebman HA, Zhang L, Hu Y, Miyakawa Y, et al.; LUNA3 Trial Group. Safety and efficacy of rilzabrutinib vs placebo in adults with immune thrombocytopenia: the phase 3 LUNA3 study. Blood. 2025;145:2914-2926. (Among 202 adults with chronic immune thrombocytopenia treated with rilzabrutinib [400 mg twice daily] or placebo for 12 weeks, a platelet response occurred in 64% vs 23%, while adverse events were mostly mild to moderate diarrhea, nausea, headache, abdominal pain, and ALT elevations were uncommon [2% vs 3%] and all were less than 3 times ULN). 40090011
Giménez-Arnau A, Ferrucci S, Ben-Shoshan M, Mikol V, Lucats L, Sun I, Mannent L, et al. Rilzabrutinib in antihistamine-refractory chronic spontaneous urticaria: The RILECSU Phase 2 Randomized Clinical Trial. JAMA Dermatol. 2025;161:679-687. (Among 160 adults with chronic spontaneous urticaria refractory to antihistamines treated with rilzabrutinib [400, 800, or 1200 mg daily] vs placebo, clinical itch and urticaria scores improved with the highest dose and adverse events were mild to moderate diarrhea, nausea, and headache, while 4 patients on rilzabrutinib developed ALT elevations above 3 times ULN but all resolved, 3 while continuing therapy). 40266575
Kircik L, Tsianakas A, Valenzuela F, Mikol V, Nian G, Mannent L, Baret-Cormel L. Efficacy and safety of rilzabrutinib in patients with moderate-to-severe atopic dermatitis: 16-week results from a proof-of-concept phase II clinical trial. Br J Dermatol. 2025;193:424-433 (Among 124 patients with atopic dermatitis treated with rilzabrutinib [800 or 1200 mg daily] or placebo daily for 16 weeks, improvements in the Eczema Area and Severity Index were slightly greater with treatment [54% and 47% vs 47% and 43%] while adverse events were mild to moderate diarrhea and nausea, with no treatment related serious adverse events, and no patient on rilzabrutinib developed ALT elevations above 3 times ULN). 40317187
Kuter DJ, Ghanima W, Cooper N, Liebman HA, Zhang L, Hu Y, Miyakawa Y, et al. Clinical activity and safety of rilzabrutinib in patients with previously treated immune thrombocytopenia (LUNA3): results from the open-label period of a phase 3 trial. Lancet Haematol. 2026;S2352-3026(26)00193-6. PMID: 42753771 (Among 180 patients with chronic immune thrombocytopenia treated with rilzabrutinib [400 mg twice daily] for a median of 24 weeks, clinical responses were achieved in 23%, while treatment-related adverse events occurred in 26% and included diarrhea [9%], nausea [9%], and ALT elevations in 2 patients [1.1%] which were above 5 times ULN in 1 [0.6%]).

## OTHER REFERENCE LINKS

1. Recent References on Rilzabrutinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Rilzabrutinib%20+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Rilzabrutinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Rilzabrutinib)